# Tibolone

## OVERVIEW

### Introduction

Tibolone is a synthetic estrogen used for treatment of symptoms of menopause and prevention of osteoporosis. Tibolone has been associated with rare instances of acute, clinically apparent liver injury.

### Background

Tibolone (tye' boe lone) is a synthetic estrogen-like steroid hormone which acts as an agonist of multiple type I steroid receptors and thus has weak estrogenic and progestational activities as well as some androgenic properties. The parent compound has no activity, but undergoes tissue-specific metabolism via a sulfatase to an active form which provides estrogenic effects without the need for concurrent progesterone administration. Tibolone also appears to have reduced estrogenic activity in breast tissue. It has been shown to be effective against the symptoms of menopause and in prevention of postmenopausal osteoporosis; it is approved in several European countries, but not the United States. Tibolone is available as 1.25 and 2.5 mg tablets under the brand name Livial. Side effects include vaginal bleeding, abdominal pain, weight gain, bloating, breast tenderness, genital pruritus and vaginitis. Uncommon but potentially severe adverse events include an increased rate of venous thromboses and cerebrovascular ischemic stokes.

### Hepatotoxicity

In large scale prospective studies, tibolone has been associated with a low rate of transient serum aminotransferase levels, being greater than 3 times the upper limit of normal in 0.9% of tibolone versus 0.2% of placebo recipients, but instances of clinically apparent acute liver injury were not reported. In Europe, where tibolone has been in clinical use, there have been isolated reports of clinically apparent liver injury arising 6 to 12 months after starting and associated with a hepatocellular pattern of serum enzyme elevations and jaundice. Reported cases were self-limited and resolved within 2 to 6 months of stopping. Immunoallergic features were not present nor were autoantibodies.

Likelihood score: C (probable cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of liver injury due to tibolone is not known. The clinically apparent liver injury has not resembled that of the cholestatic jaundice associated with estrogens and has features of idiosyncratic liver injury.

### Outcome and Management

The severity of liver injury due to tibolone has varied from mild, transient serum enzyme elevations to moderately severe acute hepatitis. No instances of acute liver failure, death, or chronic hepatitis have been linked to tibolone use. A single instance of vanishing bile duct syndrome was reported after tibolone use in combination with St. John’s wort. Rechallenge studies have not been done.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Tibolone – Livial®

DRUG CLASS

Synthetic Estrogen

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Tibolone)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Tibolone | 5630-53-5 | C21-H28-O2

## ANNOTATED BIBLIOGRAPHY

References updated: 02 September 2020

Zimmerman HJ. Hormonal derivatives and related drugs. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 555-88. (Expert review of hepatotoxicity published in 1999; estrogenic steroids and oral contraceptives are discussed, but not tibolone).
Chitturi S, Farrell GC. Adverse effects of hormones and hormone antagonists on the liver. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 605-19. (Review of hepatotoxicity of estrogenic hormones; tibolone is not discussed).
Isaacs C, Wellstein A, Riegel AT. Hormones and related agents in the therapy of cancer. In, Brunton LL, Hilal-Dandan, R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1237-47. (Textbook of pharmacology and therapeutics).
Blanco Sampascual S, de Las Heras Niño B, Cabezudo Gil P, Ruiz Eguiluz P, Orive Cura V. (2002). Gastroenterol Hepatol. (51 year old woman developed jaundice and pruritus 1 year after starting tibolone [bilirubin 43.7 mg/dL, ALT 1800 U/L, Alk P 407 U/L], resolving within 6 months of stopping).
Swegle JM, Kelly MW. (2004). Tibolone: a unique version of hormone replacement therapy. Ann Pharmacother. (Review of the structure, pharmacology, mechanism of action and clinical efficacy of tibolone, which has been available in Europe for several years, but not in the U.S.; side effects include vaginal bleeding, abdominal pain, weight gain, bloating, breast tenderness and vaginitis; no mention of hepatotoxicity).
Rigato I, Cravatari M, Avellini C, Ponte E, Crocè SL, Tiribelli C. (2007). Drug-induced acute cholestatic liver damage in a patient with mutation of UGT1A1. Nat Clin Pract Gastroenterol Hepatol. (54 year old woman developed jaundice 6 months after starting tibolone and 2 months after starting flavoxate [bilirubin 12.7 mg/dL, ALT 1938 U/L, Alk P 244 U/L], resolving in 2 months of stopping both).
Bai W, Henneicke-von Zepelin HH, Wang S, Zheng S, Liu J, Zhang Z, Geng L, et al. (2007). Efficacy and tolerability of a medicinal product containing an isopropanolic black cohosh extract in Chinese women with menopausal symptoms: a randomized, double blind, parallel-controlled study versus tibolone. Maturitas. (Controlled trial of tibolone vs black cohosh in 244 women with menopausal symptoms; "Adverse events that might have been interpreted as sign of a liver dysfunction did not occur").
Cummings SR, Ettinger B, Delmas PD, Kenemans P, Stathopoulos V, Verweij P, Mol-Arts M, et al., LIFT Trial Investigators. (2008). The effects of tibolone in older postmenopausal women. N Engl J Med. (Controlled trial of tibolone vs placebo in 4538 women with osteoporosis; ALT elevations >3 times ULN occurred in 0.9% on tibolone and 0.2% placebo, no mention of clinically apparent liver injury; the study was stopped because of increased incidence of stroke on tibolone).
Etogo-Asse F, Boemer F, Sempoux C, Geubel A. (2008). Acute hepatitis with prolonged cholestasis and disappearance of interlobular bile ducts following tibolone and Hypericum perforatum (St. John's wort). Case of drug interaction?. Acta Gastroenterol Belg. (57 year old woman developed jaundice 2 years after starting tibolone and 10 weeks after starting St. John's wort [bilirubin 6.3 rising to 37.0 mg/dL, ALT 424 U/L, Alk P 162 U/L, ANA 1:320], with slow improvement and biopsy indicating bile duct loss; authors suggested an interaction between herbal and tibolone).
Chen J, Gao H, Li Q, Cong J, Wu J, Pu D, Jiang G. (2014). Efficacy and safety of remifemin on peri-menopausal symptoms induced by post-operative GnRH-a therapy for endometriosis: a randomized study versus tibolone. Med Sci Monit. (Among 116 Chinese women with endometriosis undergoing gonadotrophin releasing hormone therapy and treated with either remifemin [black cohosh] or tibolone, menopausal symptoms and hot flashes/sweating scores increased in both groups to a similar degree and there were no significant changes in ALT, AST or creatinine levels).
Chen JM, Gao HY, Ding Y, Yuan X, Wang Q, Li Q, Jiang GH. (2015). Efficacy and safety investigation of Kuntai capsule for the add-back therapy of gonadotropin releasing hormone agonist administration to endometriosis patients: a randomized, double-blind, blank- and tibolone-controlled study. Chin Med J (Engl). (Among 30 Chinese women with endometriosis undergoing gonadotrophic releasing hormone therapy, menopausal symptoms and hot flashes were less in those receiving tibolone and a Traditional Chinese medication [Kuntai] than those on no therapy and there were no significant rises in ALT or AST levels in any group).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to tibolone which was not approved for use in the United States).
Macedo G, Silva M, Vilas-Boas F, Lopes S, Peixoto A, Carneiro F. (2017). Tibolone-induced acute hepatitis: Well-known drug, little-known complication. Gastroenterol Hepatol. (45 year old woman was found to have asymptomatic elevation of liver tests 6 months after starting tibolone for menopausal symptoms [bilirubin normal, ALT 600 U/L, Alk P normal], which fell into the normal range within 3 weeks of stopping).
Alshehre SM, Duffy S, Jones G, Ledger WL, Metwally M. (2020). A prospective, single-centre, single-arm, open label study of the long term use of a gonadotropin releasing hormone agonist (Tin SR, 11.25 mg) in combination with Tibolone add-back therapy in the management of chronic cyclical pelvic pain. Reprod Biol Endocrinol. (Among 27 women receiving gonadotrophin releasing hormone agonists as therapy for cyclic pelvic pain treated with tibolone, there were no serious adverse events and although ALT levels rose slightly, they remained in the normal range).

## OTHER REFERENCE LINKS

1 Recent References on Tibolone: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Tibolone/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Tibolone: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Tibolone)